# Triclabendazole

## OVERVIEW

### Introduction

Triclabendazole is an oral anthelmintic used in the treatment of chronic fascioliasis also known as liver flukes. Triclabendazole therapy is generally well tolerated but can be accompanied by abdominal pain, nausea and mild liver test abnormalities, which are probably due to the expulsion of dead or dying flukes rather than hepatic injury due to the therapy.

### Background

Triclabendazole (tri cla ben’ da zole) is a benzimidazole derivative and anthelmintic used as therapy of fascioliasis (liver flukes). Fasciola hepatica and gigantica are two species of trematodes that infect livestock and can secondarily infect humans. Fascioliasis is found in more than 50 countries, especially where sheep or cattle are reared. Except for parts of Western Europe, human fascioliasis occurs mainly in developing countries. The life cycle of Fasciola starts with release of immature eggs in the stool of infected humans or animals, which after several weeks release miracidia. The miracidia attach to amphibian snails, penetrate their skin and undergo asexual reproduction into hundreds of cercariae which leave the snails and encyst and attach to aquatic vegetation becoming metacercariae, the form that infects humans, livestock and other mammals. Once ingested Fasciola passes through the duodenal wall into the peritoneum, through Glisson’s capsule into the liver where it migrates to the biliary tree and matures into adult flukes. Acute fascioliasis occurs as the organism traverses the duodenum and liver is associated with fever, abdominal pains, urticaria, eosinophilia, hepatosplenomegaly and jaundice. With chronic infection, biliary symptoms and obstruction can occur with recurrent cholangitis and pancreatitis. The diagnosis of chronic fascioliasis is made by finding Fasciola eggs in stool or by specific serologic tests for antibodies. Triclabendazole is currently the drug of choice for therapy of chronic fascioliasis and, with correct dosing, can achieve cure in 75% to 95% of patients. Triclabendazole has been used as an anthelmintic in humans for three decades, but was first formally approved for use in the United States in 2019 on the basis of published and historic studies of its efficacy and safety. Current indications are for patients, 6 years and older, with documented chronic fascioliasis. The recommended treatment regimen is two doses of 10 mg/kg given orally 12 hours apart. Documentation of the absence of Fasciola eggs in stool samples taken 3 months after therapy is generally considered evidence of efficacy and cure. Side effects starting on the day of treatment and lasting a few days include abdominal pain [in 50% to 95% of patients], nausea and vomiting, loss of appetite, diarrhea, rash, urticaria, pruritus and eosinophilia. Severe adverse events are rare. In laboratory animals, triclabendazole can prolong the QT interval.

### Hepatotoxicity

The published and historic controlled trials of triclabendazole in chronic fascioliasis rarely described adverse event rates or blood test results except for eosinophilia. Instances of enzyme elevations and jaundice have been described, but patients with chronic fascioliasis often have minor elevations in liver tests. Furthermore, the common side effects of treatment are most likely due to the effects of sudden expulsion of the liver flukes from the biliary tree, which can result in transient serum ALT and alkaline phosphatase elevations and even jaundice. There are no reports of serious liver injury, acute liver failure, vanishing bile duct syndrome or chronic hepatitis after triclabendazole therapy. There are reports of mixed or cholestatic hepatic injury and vanishing bile duct syndrome linked to other benzimidazole anthelmintic agents such as thiabendazole and albendazole. There is also reported association between Fasciola infection with the potential for bile duct obstruction and sequelae.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The most likely reason for lack of clinically apparent hepatotoxicity from triclabendazole is the single day therapeutic regimen. Triclabendazole is metabolized in the liver, largely by CYP 1A2 and 2C19 and it is theoretically susceptible to drug-drug interactions. Even with repeated dosing, there have been no reports of serious adverse events from triclabendazole therapy.

Drug Class: Anthelmintic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Triclabendazole – Egaten®

DRUG CLASS

Anthelmintic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Triclabendazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Triclabendazole | 68786-66-3 | C14-H9-Cl3-N2-O-S

## ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2026

Zimmerman HJ. Anthelminthics. Hepatic injury from the treatment of infectious and parasitic disease. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 626-8. (Expert review of anthelmintics discusses albendazole, mebendazole and thiabendazole but not triclabendazole, the bendazoles being often associated with transient liver enzyme elevations and rarely linked to acute, symptomatic cholestatic liver injury).
Keiser J, McCarthy J, Hotez P. Chemotherapy of helminth infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1001-9. (Textbook of pharmacology and therapeutics mentions that liver dysfunction is the most common side effect of albendazole, but that the bendazoles as a group have excellent safety profiles).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/208711Orig1s000MultidisciplineR.pdf (FDA review of efficacy and safety of triclabendazole in support of its approval in the US, mentions that liver test abnormalities can be seen in some patients as a part of their Fasciola infection and some abnormalities arising shortly after treatment could be related to expulsion of the dead or dying flukes being associated with abdominal pain, urticaria and eosinophilia).
Hien TT, Truong NT, Minh NH, Dat HD, Dung NT, Hue NT, Dung TK, et al. A randomized controlled pilot study of artesunate versus triclabendazole for human fascioliasis in central Vietnam. Am J Trop Med Hyg. 2008;78:388-92. (Among 100 Vietnamese patients with chronic fascioliasis treated with artesunate or triclabendazole, cure rates at 3 months were 76% vs 92%; serum enzyme and bilirubin levels were similar between the two groups before and after therapy; side effects were not discussed). 18337331
Keiser J, Sayed H, el-Ghanam M, Sabry H, Anani S, el-Wakeel A, Hatz C, et al. Efficacy and safety of artemether in the treatment of chronic fascioliasis in Egypt: exploratory phase-2 trials. PLoS Negl Trop Dis. 2011;5:e1285. (Among 20 adults with chronic fascioliasis wo had failed therapy with artemether, response rates to triclabendazole were 67-75% while adverse events were similar to those with artemether, being abdominal pain, nausea, vomiting, diarrhea, headache and fatigue, and liver tests results showed ‘no significant differences following administration of triclabendazole”). 21909440
Webb CM, Cabada MM. Recent developments in the epidemiology, diagnosis, and treatment of Fasciola infection. Curr Opin Infect Dis. 2018;31:409-414. (Review of the fascioliasis, the most widely distributed trematode infection worldwide, the life-cycle of Fasciola hepatica, clinical course of the infection, diagnosis, and management; states that triclabendazole is the drug of choice for its therapy with response rates as high as 90%). 30113327
Gandhi P, Schmitt EK, Chen CW, Samantray S, Venishetty VK, Hughes D. Triclabendazole in the treatment of human fascioliasis: a review. Trans R Soc Trop Med Hyg. 2019;113:797-804. (Review of the efficacy and safety of triclabendazole for human fascioliasis, first used in veterinary medicine was evaluated in humans in the 1990s leading to approval for use in Egypt in 1997, in France in 2002 but not in the US until 2019; cure rates of 69-100% in human trials, it “appears to be well tolerated” most adverse events being due to expulsion of the dead or dying flukes). 31638149
Caravedo MA, Cabada MM. Human fascioliasis: current epidemiological status and strategies for diagnosis, treatment, and control. Res Rep Trop Med. 2020;11:149-158. (Review of the life-cycle, epidemiology, clinical features and therapy of fascioliasis). 33273878
de Moraes J, Geary TG. FDA-Approved antiparasitic drugs in the 21st century: a success for helminthiasis? Trends Parasitol. 2020;36:573-575. (Helminthiasis affects a sizeable proportion of the world’s population but largely in resource limited countries and among people living in poverty; the FDA has recently approved two novel agents for helminthic diseases including moxidectin for onchocerciasis in 2018 and triclabendazole for fascioliasis in 2019, agents that will play a very important role in world health). 32387059
Terashima A, Canales M, Maco V, Marcos LA. Observational study on the effectiveness and safety of multiple regimens of triclabendazole in human fascioliasis after failure to standard-of-care regimens. J Glob Antimicrob Resist. 2021;25:264-267. (Among 27 patients with chronic fascioliasis seen at a single center in Peru between 2002 and 2018, who had failed an initial standard of care course of triclabendazole and were treated with 1 to 9 repeated courses for longer period or with higher doses, 20 [74%] were ultimately cured and “it seemed to be well tolerated”). 33862276
Morales ML, Tanabe MB, White AC Jr, Lopez M, Bascope R, Cabada MM. Triclabendazole treatment failure for Fasciola hepatica infection among preschool and school-age children, Cusco, Peru. Emerg Infect Dis. 2021;27:1850-1857. (Among 53 Peruvian children with chronic fascioliasis treated with directly observed therapy with triclabendazole [usually single dose], only 54% achieved a cure with the first treatment and fewer with each subsequent treatment course, so that after 4 courses, 12% of children were still infected; no mention of adverse events). 34152949
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 5 [1%] were attributed to albendazole, 1 to mebendazole, 1 to thiabendazole, but none to triclabendazole or fenbendazole). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Triclabendazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Triclabendazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Triclabendazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Triclabendazole)